# Raltegravir

## OVERVIEW

### Introduction

Raltegravir is an integrase inhibitor, the first of the class of antiviral agents active against the human immunodeficiency virus (HIV) that targets the viral integrase. Raltegravir is used in combination with other antiretroviral agents in the treatment of HIV infection. Raltegravir has not been linked convincingly to serum aminotransferase elevations during therapy or to episodes of acute, clinically apparent liver injury.

### Background

Raltegravir (ral teg' ra vir) is relatively new antiretroviral drug that targets the HIV integrase, one of the three enzymes involved in viral replication. Raltegravir blocks the binding site of the HIV integrase and prevents the strand transfer activity and integration of the provirus into the host genome. Raltegravir has both in vitro and in vivo activity against HIV, and several randomized controlled trials have shown that it leads to significant decline in HIV RNA levels and rises in peripheral CD4 T cell counts. Raltegravir was given accelerated approval for use in HIV infection in the United States in 2007 and is currently used in an increasing proportion of antiretroviral regimens. Raltegravir is available as 400 mg tablets generically and under the brand name Isentress. The recommended dose regimen is 400 mg twice daily in combination with other classes of antiretroviral agents. Common side effects include diarrhea, headache, nausea and fever.

### Hepatotoxicity

In large clinical trials, therapy with raltegravir was associated with alanine aminotransferase (ALT) elevations in up to 10% and elevations of greater than 5 times the upper limit of normal (ULN) in 3% to 4% of patients, but these rates were similar to those in comparator groups receiving matched background optimized antiretroviral therapy without raltegravir. These elevations were not associated with clinical symptoms and generally did not require dose modification. There have been no published reports of clinically apparent cases of liver injury attributed to raltegravir. Nevertheless, the product label for raltegravir mentions hepatitis and hepatic failure as a potential adverse reactions, but without specific details. Raltegravir has also been linked to instances of Stevens Johnson syndrome and drug hypersensitivity reactions, which can be accompanied by hepatic involvement. Finally, initiation of antiretroviral therapy with raltegravir can result in the immune reconstitution syndrome which may cause a worsening or flare of an accompanying chronic hepatitis B or C in coinfected individuals.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Raltegravir is metabolized by the liver and undergoes glucuronidation as a part of its metabolic clearance. It does not have an effect on the CYP 450 system.

### Outcome and Management

Serum enzyme elevations during raltegravir therapy are not uncommon but are generally mild to moderate in severity and often are attributable to other agents taken in combination with raltegravir. Nevertheless, aminotransaferase elevations above 5 times the ULN, if confirmed, warrant dose interruption and evaluation for other causes of acute liver injury. There is no information about the cross sensitivity to liver injury among the various HIV integrase inhibitors, but some degree of cross reactivity should be expected.

Drug Class: Antiviral Agents

Other Drugs in the Subclass, Integrase Strand Transfer Inhibitors: Bictegravir, Cabotegravir, Dolutegravir, Elvitegravir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Raltegravir – Isentress®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Raltegravir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Raltegravir | 518048-05-0 | C20-H21-F-N6-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2018

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents including raltegravir).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-64. (Textbook of pharmacology and therapeutics).
https://hivinfo.nih.gov/hiv-source/medical-practice-guidelines/hiv-treatment-guidelines (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Markowitz M, Nguyen BY, Gotuzzo E, Mendo F, Ratanasuwan W, Kovacs C, Prada G, et al. (2007). Protocol 004 Part II Study Team. Rapid and durable antiretroviral effect of the HIV-1 Integrase inhibitor raltegravir as part of combination therapy in treatment-naive patients with HIV-1 infection: results of a 48-week controlled study. J Acquir Immune Defic Syndr. (Results of a phase II trial of 4 doses of raltegravir vs efavirenz in 198 patients on background optimized regimen for 48 weeks; ALT and AST elevations were rare and similar in rate in both groups).
Grinsztejn B, Nguyen BY, Katlama C, Gatell JM, Lazzarin A, Vittecoq D, Gonzalez CJ, et al., Protocol 005 Team. (2007). Safety and efficacy of the HIV-1 integrase inhibitor raltegravir (MK-0518) in treatment-experienced patients with multidrug-resistant virus: a phase II randomised controlled trial. Lancet. (Results of phase II trial of in 133 patients with HIV given raltegravir and 45 placebo in combination with background antiretrovirals for at least 24 weeks; tolerability with raltegavir therpay was no different than placebo, although pruritus [4.5% vs 0%] and hyperbilirubinemia [6.8% vs 4.4%] were more common; ALT levels not reported).
(2008). Two new drugs for HIV infection. Med Lett Drugs Ther. (Concise summary of role of ralegravir and maraviroc in treatment-refractory or treatment-experienced patients with HIV infection; hepatotoxicity was reported with maraviroc [with rash and eosinophilia], but not with raltegravir).
Croxtall JD, Lyseng-Williamson KA, Perry CM. (2008). Raltegravir. Drugs. (Brief review of structure, activity, pharmacokinetics and pharmacodynamics, clinical efficacy and tolerability of raltegravir; no mention of hepatotoxicity).
Evering TH, Markowitz M. (2008). Raltegravir: an integrase inhibitor for HIV-1. Expert Opin Investig Drugs. (Review of raltegravir, first integrase inhibitor of HIV approved for use in US, no mention of hepatotoxicity).
Cocohoba J, Dong BJ. (2008). Raltegravir: the first HIV integrase inhibitor. Clin Ther. (Review of the mechanism of action, pharmacokinetics, and phase I-III studies of raltegravir; in combined phase III studies, ALT elevations above 5 times ULN occurred in 4.3% of 462 raltegravir treated vs 3.4% of 237 placebo treated patients who were receiving optimized background therapy; no hepatic serious adverse events were reported).
Siegel MO, Kan VL, Benator DA. (2008). Raltegravir for postexposure prophylaxis following occupational exposure to HIV. AIDS. (Two health care workers with multidrug resistant HIV exposures were given raltegravir with 3-4 other agents, no apparent side effects from raltegravir and neither became HIV positive).
Fleischbein E, O'Brien J, Martelino R, Fenstersheib M. (2008). Elevated alkaline phosphatase with raltegravir in a treatment experienced HIV patient. AIDS. (45 year old man with AIDS developed elevated Alk P [85 rising to 1053 U/L], which resolved upon stopping and recurred on rechallenge with raltegravir; serum bilirubin, ALT and GGT levels were normal, but authors suspected liver as the source anyways).
Steigbigel RT, Cooper DA, Kumar PN, Eron JE, Schechter M, Markowitz M, Loutfy MR, et al., BENCHMRK Study Teams. (2008). Raltegravir with optimized background therapy for resistant HIV-1 infection. N Engl J Med. (Combined results of 2 large trials of raltegravir [n=462] vs placebo [n=237] with optimized background antiretrovirals for HIV infection reported similar rates of adverse events in two groups; ALT >5 times ULN in 4.3% vs 3.4%, Alk P >5 times ULN in 1.1% vs 1.7%, bilirubin >2.5 times ULN in 3.7% vs 2.5%; all not significantly different; no reports of hepatitis, one case of liver cancer).
Hammer SM, Eron JJ, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al., International AIDS Society-USA. (2008). Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA. (Recommendations on use of antiviral therapy in adults with HIV infection including use of recently approved agents: raltegravir, maraviroc and etravirine).
Evering TH, Markowitz M. (2008). Raltegravir: an integrase inhibitor for HIV-1. Expert Opin Investig Drugs. (Review of chemical structure, mechanism of action, pharmacology, clinical efficacy and safety of raltegravir; no mention of ALT elevations, jaundice or clinically apparent hepatotoxicity; rates of side effects were similar in raltegravir to those in comparator arms).
Hughes CA, Robinson L, Tseng A, MacArthur RD. (2009). New antiretroviral drugs: a review of the efficacy, safety, pharmacokinetics, and resistance profile of tipranavir, darunavir, etravirine, rilpivirine, maraviroc, and raltegravir. Expert Opin Pharmacother. (Review of tipranavir, darunavir, etravirine, rilpivirine, maraviroc and raltegravir; "Raltegravir was well tolerated.." with similar rates of adverse events for raltegavir and comparator arms).
Lennox JL, DeJesus E, Lazzarin A, Pollard RB, Madruga JV, Berger DS, Zhao J, et al., STARTMRK investigators. (2009). Safety and efficacy of raltegravir-based versus efavirenz-based combination therapy in treatment-naï patients with HIV-1 infection: a multicentre, double-blind randomised controlled trial. Lancet. (Trial comparing raltegravir to efavirenz and optimized background antiretroviral therapy for 48 weeks in 566 patients with HIV infection; ALT and AST elevations >5 times ULN occurred in 2% of both groups).
Moreno A, Quereda C, Fortún J, Bárcena R, Pérez-Elías MJ, Casado JL, Rodríguez-Sagrado MA, et al. (2010). Safe co-administration of raltegravir, pegylated-interferon and, ribavirin in HIV individuals with hepatitis C virus-related liver damage. AIDS. (Among 5 patients with HIV infection and severe hepatitis C treated with peginterferon and ribavirin while on an antiretroviral regimen including raltegravir, 2 had a sustained response [both genotype 3], 2 did not respond and 1 died of a bacterial infection).
Vispo E, Mena A, Maida I, Blanco F, Cordoba M, Labarga P, Rodriguez-Novoa S, et al. (2010). Hepatic safety profile of raltegravir in HIV-infected patients with chronic hepatitis C. J Antimicrob Chemother. (Among 218 patients with HIV starting on raltegravir, ALT elevations occurred in 8% without and 25% with HCV coinfection over a 2 year period, and elevations >5 times ULN occurred only in coinfected patients [n=3; 4%], and each could be attributed to other factors and resolved without stopping raltegravir).
Ortu F, Weimer LE, Floridia M, Manconi PE. (2010). Raltegravir, tenofovir, and emtricitabine in an HIV-infected patient with HCV chronic hepatitis, NNRTI intolerance and protease inhibitors-induced severe liver toxicity. Eur J Med Res. (43 year old woman with HIV/HCV coinfection who developed symptomatic elevations of serum enzymes on saquinavir, fosamprenavir and again on darunavir, was adequately maintained on tenofovir/emtricitabine and raltegravir).
Rockstroh J, Teppler H, Zhao J, Sklar P, Harvey C, Strohmaier K, Leavitt R, et al. (2012). Safety and efficacy of raltegravir in patients with HIV-1 and hepatitis B and/or C virus coinfection. HIV Med. (Review of 3 trials of raltegravir for rate of adverse events in patients with HIV infection with and without hepatitis B or C; ALT elevations >5 times ULN occurred in higher proportion of patients with hepatitis coinfection, but rates were similar with raltegravir as with comparator arms).
Macías J, Neukam K, Portilla J, Iribarren JA, de Los Santos I, Rivero A, Márquez M, et al. (2011). HEPRAL study team. Liver tolerance of raltegravir-containing antiretroviral therapy in HIV-infected patients with chronic hepatitis C. J Antimicrob Chemother. (Among 108 patients with HIV-HCV coinfection started on antiretroviral therapy including raltegravir, 10 patients [9.3%] developed ALT elevations >5 times ULN, but all resolved and no patient discontinued raltegravir permanently for liver test abnormalities).
Mangiafico L, Perja M, Fusco F, Riva S, Mago D, Gringeri A. (2012). Safety and effectiveness of raltegravir in patients with haemophilia and anti-HIV multidrug resistance. Haemophilia. (Among 7 patients with hemophilia and HIV-HCV coinfection on antiretroviral regimens including raltegravir, only 1 had an increase in liver enzyme levels and “cholestasis”, which resolved promptly when maraviroc was discontinued while raltegravir was continued).
Rockstroh J, Sklar P, Wan H, Teppler H, Harvey C, Strohmaier K, Leavitt R, et al. (2012). Safety and efficacy of raltegravir in patients co-infected with HIV and hepatitis B and/or C virus: complete data from Phase III double-blind studies. J Int AIDS Soc. (Abstract: among 743 raltegravir and 519 comparator treated subjects, ALT elevations >5 times ULN occurred in similar proportions of patients, but were more common in those with HCV or HBV coinfection [6-15%] than in those with HIV infection alone [3-4%]).
Annandale D, Richardson C, Fisher M, Richardson D. (2012). Raltegravir-based post-exposure prophylaxis (PEP): a safe, well-tolerated alternative regimen. J Int AIDS Soc. (Abstract: among 33 persons given a 28 day course of three antiretroviral drugs including raltegravir after a high risk HIV exposure, none developed significant liver or renal toxicity).
Mateo-Carrasco H, Gálvez-Contreras MC, Fernández-Ginés FD, Nguyen TV. (2012). Elevated liver enzymes resulting from an interaction between raltegravir and Panax ginseng: a case report and brief review. Drug Metabol Drug Interact. (Abstract: patient with chronic hepatitis C and HIV infection on long term therapy with raltegravir, lopinavir/r, aspirin and esomeprazole developed jaunidce 39 days after starting ginseng, which improved on stopping ginseng; the authors suggest that drug-drug interactions accounted for the hepatotoxicity).
Weimer LE, Fragola V, Floridia M, Guaraldi G, Ladisa N, Francisci D, Bellagamba R, et al., ISS-NIA Study Group. (2013). Response to raltegravir-based salvage therapy in HIV-infected patients with hepatitis C virus or hepatitis B virus coinfection. J Antimicrob Chemother. (Among 275 patients with HIV infection who were switched to a raltegravir containing antiretroviral regimen, 23 developed ALT or AST elevations above 5 times ULN [16% in coinfected; 3.6% non-coinfected], but no details given).
Surgers L, Lacombe K. (2013). Hepatoxicity of new antiretrovirals: a systematic review. Clin Res Hepatol Gastroenterol. (Review of evidence of liver injury in large clinical trials of newer antiretroviral agents including raltegravir concluded that "the overall hepatic tolerance is far better with the novel drugs in this review than with former ARV regimens"; ALT elevations occurred with equal frequency in raltegravir and comparator arms, and one patient on raltegravir developed DRESS syndrome).
Cahn P, Pozniak AL, Mingrone H, Shuldyakov A, Brites C, Andrade-Villanueva JF, Richmond G, et al. (2013). extended SAILING Study Team. Dolutegravir versus raltegravir in antiretroviral-experienced, integrase-inhibitor-naive adults with HIV: week 48 results from the randomised, double-blind, non-inferiority SAILING study. Lancet. (Among 715 patients with HIV infection treated with either dolutegravir or raltegravir combined with background antiretroviral therapy, adverse events were similar between the two groups and 3% vs 2% developed ALT elevations above 5 times ULN; no mention of clinically apparent liver injury).
Eron JJ, Cooper DA, Steigbigel RT, Clotet B, Gatell JM, Kumar PN, Rockstroh JK, et al., BENCHMRK Study Teams. (2013). Efficacy and safety of raltegravir for treatment of HIV for 5 years in the BENCHMRK studies: final results of two randomised, placebo-controlled trials. Lancet Infect Dis. (Combined analysis of two large trials of raltegravir vs placebo in 699 patients with HIV infection for up to 5 years found a low rate of ALT elevations above 5 times ULN [6-7%] that was similar to the rate in controls [4.2%]; no mention of clinically apparent liver injury).
Vispo E, Fernández-Montero JV, Labarga P, Barreiro P, Soriano V. (2013). Low risk of liver toxicity using the most recently approved antiretroviral agents but still increased in HIV-hepatitis C virus coinfected patients. AIDS. (Among 1982 HIV infected persons with 2717 initation episodes of antiretroviral therapy, 9% developed enzyme elevations, 6% in HCV negative and 17% in HCV positive subjects, but enzyme levels were above 5 times ULN in only 0.4% of cases).
Hurt CB, Napravnik S, Moore RD, Eron JJ. (2014). Hepatic safety and tolerability of raltegravir among HIV patients coinfected with hepatitis B and/or C. Antivir Ther. (Among 456 adults with HIV infection treated with raltegravir, those coinfected with HCV [n=138] or HBV [n=17] or both [n=11] were more likely to have serum enzyme elevations at baseline and had a 2.7-fold increased rate of severe elevations [above 5 times ULN] during therapy).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were due to antiretroviral agents, but none were attributed to raltegravir or other HIV integrase inhibitors).
de Castro N, Braun J, Charreau I, Lafeuillade A, Viard JP, Allavena C, Aboulker JP, et al., EASIER ANRS 138 study group. (2016). Incidence and risk factors for liver enzymes elevations in highly treatment-experienced patients switching from enfuvirtide to raltegravir: a sub-study of the ANRS-138 EASIER trial. AIDS Res Ther. (Extensive analysis of ALT elevations that occurred in 169 HIV positive patients who were maintained on enfuvirtide or switched to raltegravir suggested that the elevations were most likely due to concurrent tipranavir use).
Neukam K, Mira JA, Collado A, Rivero-Juárez A, Monje-Agudo P, Ruiz-Morales J, Ríos MJ, et al., HEPAVIR SEG-HEP-2007 Study Group of the Sociedad Andaluza de Enfermedades Infecciosas (SAEI). (2016). Liver toxicity of current antiretroviral regimens in HIV-infected patients with chronic viral hepatitis in a real-life setting: The HEPAVIR SEG-HEP Cohort. PLoS One. (Among 192 adults with HIV and either HBV or HCV coinfection who were started on antiretroviral therapy and monitored under "real life" conditions, ALT and AST elevations above 5 times ULN occurred in 10 patients [5%], but all were self limited and none required discontinuation of therapy for this reason).
Cahn P, Kaplan R, Sax PE, Squires K, Molina JM, Avihingsanon A, Ratanasuwan W, et al., ONCEMRK Study Group. (2017). Raltegravir 1200 mg once daily versus raltegravir 400 mg twice daily, with tenofovir disoproxil fumarate and emtricitabine, for previously untreated HIV-1 infection: a randomised, double-blind, parallel-group, phase 3, non-inferiority trial. Lancet HIV. (Among 802 adults with HIV infection treated with once or twice daily raltegravir for 48 weeks, efficacy and tolerability were similar in the two groups, while ALT elevations above 2.5 times ULN occurred in 2.5% of patiients on once vs 0.8% on twice daily raltegravir).

## OTHER REFERENCE LINKS

1 Recent References on Raltegravir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Raltegravir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Raltegravir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Raltegravir)